# Interleukin Receptor Antagonists

## OVERVIEW

Interleukin-1 (IL-1) and interleukin-6 (IL-6) are potent pro-inflammatory cytokines that are synthesized by many cells throughout the body and play major roles in inflammation and cell damage associated with excessive inflammation. IL-1 is increased in inflammatory conditions and appears to play a role in autoinflammatory and autoimmune diseases. Blockage of IL-1 production or inhibition of its activity decreases inflammatory responses and may be beneficial in many diseases associated with a heightened immune response such as rheumatoid arthritis, ankylosing spondylitis, gouty arthritis, osteoarthritis, juvenile idiopathic arthritis, Still disease, Familial Mediterranean fever, periodic fever and periodic syndromes. Blockage of IL-6 activity has similar clinical activity, although it has been assessed largely in inflammatory arthritidies. At least three IL-1 receptor antagonists have been approved for use in autoinflammatory conditions in the United States. In addition, a monoclonal antibody to the IL-6 receptor has been developed and shown to have beneficial effects in rheumatoid arthritis.

Recently, several of the interleukin receptor antagonists have been assessed as therapy of the advanced hyperinflammatory state of severe COVID-19. The rationale for their use is that advanced cases of SARS-Co-2 infection are associated with high circulating levels of IL-6 and other proinflammatory cytokines that contribute to the lung and systemic inflammation and injury. Several of these anti-cytokines have been granted emergency use authorization.

The interleukin receptor antagonists have been associated with rare instances of clinically apparent liver injury that is generally mild and resolves with discontinuation.

The interleukin receptor antagonists discussed in LiverTox include the following:

- Anakinra (Recombinant IL-1Ra)
- Canakinumab (Monoclonal antibody to IL-1β receptor)
- Rilonacept (Fusion protein of IL-1 receptor1 and IL-1R accessory protein with Fc region of IgG)
- Sarilumab (Monoclonal antibody to IL-6 receptor)
- Tocilizumab (Monoclonal antibody to IL-6 receptor)